# Tafamidis

## OVERVIEW

### Introduction

Tafamidis is transthyretin stabilizer used for the treatment of adults with the cardiomyopathy of wild-type and hereditary transthyretin-mediated amyloidosis to reduce cardiovascular morbidity and mortality. Tafamidis has been associated with minor liver test abnormalities during therapy but has not been linked instances of clinically apparent liver injury.

### Background

Tafamidis (ta fam’ id is”) is a stabilizer of transthyretin, a serum protein made in the liver whose major function is transport of vitamin A and thyroxine. Rare mutations in the transthyretin gene result in misfolding of the protein and accumulation of large amyloid deposits of transthyretin molecules, most prominently in peripheral nerves and the heart. Patients with hereditary transthyretin amyloidosis typically present with polyneuropathy or autonomic dysfunction followed by cardiomyopathy, which if untreated is usually fatal within 5 to 12 years. Rarely, wild-type transthyretin can also result in overproduction and deposition of misfolded transthyretin in amyloid clusters in peripheral nerves and heart. Tafamidis causes stabilization of the transthyretin molecule in its full tetrameric form which is less likely to misfold and create amyloid clusters. In preregistration placebo controlled trials, tafamidis increased transthyretin levels in its stable form, decreased all-cause mortality and cardiovascular hospitalizations, and improved overall quality of life. Tafamidis was approved for use in the United States as treatment of the cardiomyopathy of hereditary transthyretin mediated amyloidosis in adults in 2019. It is available in two forms, as capsules of 61 mg of tafamidis under the brand name Vyndamax and as capsules of 20 mg of tafamidis meglumine under the brand name Vyndaqel. The recommended dose is 61 mg (1 capsule) daily of tafamidis or 80 mg (4 capsules) daily of tafamidis meglumine. In clinical trials of tafamidis, side effects were uncommon and similar in overall frequency to those of placebo. Transthyretin functions as a carrier and transporter of vitamin A and thyroxine, and therapy with tafamidis can alter serum concentrations of these molecules, but does not appear to affect thyroid function or vitamin A status.

### Hepatotoxicity

In the registration trials of tafamidis, ALT elevations arose in 5.7% and 4.6% of tafamidis meglumine recipients vs 2.3% on placebo and were above 3 times ULN in 0% and 2.3% vs 0.6%. However, no patient developed ALT elevations accompanied by jaundice or clinically apparent liver injury attributed to the medication. Since its approval, clinical experience with tafamidis has been limited, but there have been no published case reports of clinically apparent liver injury attributed to its use.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which tafamidis might cause liver injury is not clear. Tafamidis is a small molecule that binds to transthyretin and is probably metabolized by glucuronidation. It does not appear to have significant drug-drug interactions.

### Outcome and Management

The serum aminotransferase elevations that occur on tafamidis therapy were generally mild and not accompanied by symptoms or jaundice. Persistent ALT or AST elevations arising during therapy should lead to evaluation of their possible causes. There is no information on cross sensitivity to liver injury among the various other therapies for transthyretin-associated amyloidosis.

Drug Class: Genetic Disorder Agents

Drugs for Hereditary Transthyretin Amyloidosis: Acoramidis, Eplontersen, Inotersen, Patisiran, Vutrisiran

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Tafamidis – Vyndamax®, [Meglumine] Vyndaqel®

DRUG CLASS

Agents for genetic diseases

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Tafamidis)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Tafamidis | 594839-88-0 | C14-H7-Cl2-NO3

## ANNOTATED BIBLIOGRAPHY

References updated: 20 February 2025

Abbreviations: siRNA, small interfering RNA.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Expert review of hepatotoxicity published in 1999 before the availability of antisense therapies such as eplontersen).
FDA. Integrated Review. 2023. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2024/217388Orig1s000IntegratedR.pdf (FDA website with the product labels and integrated review of the data on efficacy and safety provided by the sponsor in support of approval of tafamidis as therapy of polyneuropathy due to transthyretin amyloidosis mentions that mild-to-moderate elevations in serum aminotransferase or alkaline phosphatase levels arose in 7.6% of tafamidis vs 6.7% of placebo recipients, but there were no ALT elevations above 3 times ULN and no cases of drug induced liver injury or aminotransferase elevations accompanied by jaundice).
Maurer MS, Grogan DR, Judge DP, Mundayat R, Packman J, Lombardo I, Quyyumi AA, et al. Tafamidis in transthyretin amyloid cardiomyopathy: effects on transthyretin stabilization and clinical outcomes. Circ Heart Fail. 2015;8:519-26. (Among 31 patients with wild-type transthyretin-mediated amyloidosis cardiomyopathy treated with tafamidis [20 mg daily] for 12 months, most patients had transthyretin stability and most adverse events were due to the underlying disease; no mention of ALT elevations or hepatotoxicity). 25872787
Barroso FA, Judge DP, Ebede B, Li H, Stewart M, Amass L, Sultan MB. Long-term safety and efficacy of tafamidis for the treatment of hereditary transthyretin amyloid polyneuropathy: results up to 6 years. Amyloid. 2017;24:194-204. (Among 93 patients with transthyretin-mediated amyloidosis with polyneuropathy enrolled in an 18 month controlled trial followed by an open label extension study for a total of up to 6 years, “therapy was generally well tolerated with no unexpected adverse events”, while ALT elevations occurred in only 3 patients [4%], none of which were accompanied with jaundice). 28758793
Maurer MS, Schwartz JH, Gundapaneni B, Elliott PM, Merlini G, Waddington-Cruz M, Kristen AV, et al.; ATTR-ACT Study Investigators. Tafamidis treatment for patients with transthyretin amyloid cardiomyopathy. N Engl J Med. 2018;379:1007-1016. (Among 441 patients with transthyretin-amyloidosis cardiomyopathy treated with tafamidis [20 or 80 mg] or placebo once daily, all-cause mortality was less with tafamidis [30% vs 43%] as was the worsening of signs and symptoms of cardiomyopathy, while adverse event rates were similar, and “results of laboratory analyses related to safety did not differ between the tafamidis and placebo groups” and “hepatobiliary disorders” arose in 9.5% vs 8.5% of patients [no details provided]). 30145929
In brief: Tafamidis (Vyndaqel; Vyndamax) for transthyretin amyloid cardiomyopathy. Med Lett Drugs Ther. 2020;62(1590):16. (Concise review of the mechanism of action, clinical efficacy, safety, and costs of tafamidis shortly after its approval in the US, mentions that the efficacy and adverse events of both doses of tafamidis [20 and 80 mg daily] were similar to those of placebo). 31999671
Damy T, Garcia-Pavia P, Hanna M, Judge DP, Merlini G, Gundapaneni B, Patterson TA, et al. Efficacy and safety of tafamidis doses in the Tafamidis in Transthyretin Cardiomyopathy Clinical Trial (ATTR-ACT) and long-term extension study. Eur J Heart Fail. 2021;23:277-285. (Further follow up of patients enrolled in the registration trial of tafamidis vs placebo [Maurer 2018] showed a continued efficacy of the two doses of tafamidis and the “incidence of adverse events in both tafamidis doses were comparable to placebo”). 33070419
Aimo A, Castiglione V, Rapezzi C, Franzini M, Panichella G, Vergaro G, Gillmore J, et al. RNA-targeting and gene editing therapies for transthyretin amyloidosis. Nat Rev Cardiol. 2022;19:655-667. (Review of the molecular approaches to therapy of transthyretin related amyloidosis including small interfering RNA [siRNA, patisiran, vutrisiran], antisense RNA [inotersen, eplontersen], CRISPR-Cas9 therapy, and molecular stabilization agents [acoramidis, tafamidis], some of which have been linked to minor serum aminotransferase elevations during therapy [vutrisiran, eplontersen], but not to clinically apparent liver injury). 35322226
Maurer MS. Overview of current and emerging therapies for amyloid transthyretin cardiomyopathy. Am J Cardiol. 2022;185 Suppl 1:S23-S34. (Review of approaches to therapy of amyloid transthyretin cardiomyopathy including the transthyretin stabilizers [tafamidis, acoramidis] and transthyretin gene silencing or knockdown agents [patisiran, vutrisiran, inotersen, eplontersen, CRISPR-Cas9]; no mention of liver related adverse events). 36371281
Ruberg FL, Maurer MS. Cardiac amyloidosis due to transthyretin protein: a review. JAMA. 2024;331:778-791. (Review of the pathogenesis, genetics, clinical features, diagnosis, and treatment of transthyretin-mediated amyloidosis cardiomyopathy; no mention of ALT elevations or hepatotoxicity). 38441582

## OTHER REFERENCE LINKS

1. Recent References on Tafamidis: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Tafamidis/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Tafamidis: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Tafamidis)